# Plecanatide

## OVERVIEW

### Introduction

Plecanatide is a minimally absorbed agonist of guanylate cyclase C receptors in the intestine and is used for treatment of chronic constipation and irritable bowel syndrome. Plecanatide has not been linked to serum enzyme elevations during treatment or to episodes of clinically apparent liver injury.

### Background

Plecanatide (ple kan’ a tide) is synthetic analogue of uroguanylin, the endogenous guanylate cyclase-C receptor agonist which acts by increasing intracellular concentrations of cyclic guanosine monophosphate (cGMP) which activates the cystic fibrosis transmembrane conductance regulator (CFTR) ion channel. The CFTR ion channel stimulates secretion of chloride and bicarbonate into the lumen of the intestine which increases intraluminal fluid and speeds intestinal transit. In several prelicensure clinical trials, plecanatide therapy was associated with increases in the number of spontaneous bowel movements, improved stool consistency and alleviation of symptoms of chronic constipation. Plecanatide was approved for therapy of chronic idiopathic constipation in adults in 2017, the second guanylate cyclase agonist approved for this indication in the United States, the first being linaclotide. Plecanatide is available in tablets of 3 mg under the brand name Trulance. The recommended dose for chronic idiopathic constipation is 3 mg once daily. It is contraindicated in children below the age of 6 years and not recommended for those below 18 years of age. Side effects include diarrhea (~5%) which is severe in less than 1%. Other adverse events include abdominal pain, bloating, flatulence and headache.

### Hepatotoxicity

In prelicensure clinical trials, plecanatide was associated with low rates of serum enzyme elevations during treatment with some degree of elevation in serum ALT or AST in 1% to 2% of treated subjects. Values rose above 5 times the upper limit of normal in only 0.2%. In these studies, there were no episodes of clinically apparent liver injury with jaundice that could be linked to plecanatide therapy. Since its approval and marketing, there have been no published reports of serum aminotransferase elevations or clinically apparent liver injury attributable to plecanatide. Thus, liver injury from plecanatide must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Plecanatide is largely active on the epithelial cells in the intestinal tract and has minimal absorption. The lack of systemic exposure and the low total daily dose (3 mg) may account for its lack of liver injury.

Drug Classes: Gastrointestinal Agents, Agents for Constipation, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Plecanatide – Trulance®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Plecanatide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Plecanatide | 467426-54-6 | C65-H104-N18-O26-S4 | Plecanatide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 16 April 2019

Zimmerman HJ. Laxatives. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721-3. (Expert review of hepatotoxicity of laxatives published in 1999 with discussion of oxyphenisatin and other agents, but not plecanatide).
Sharkey KA, McNaughton WK. Gastrointestinal motility and water flux: emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
[underlined: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/208745Orig1s000TOC.cfm] (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations above 5 times ULN occurred in 0.1% of 1673 plecanatide vs none of 841 placebo recipients and two subjects had jaundice accompanied by ALT elevations, both of whom, however, had other more likely reasons for acute liver injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to agents used for constipation or irritable bowel syndrome [IBS]). 25754159
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to gastrointestinal agents, laxatives or drugs for IBS). 20949552
Shah E, Kim S, Chong K, Lembo A, Pimentel M. Evaluation of harm in the pharmacotherapy of irritable bowel syndrome. Am J Med 2012; 125: 381-93. (Systematic review of adverse side effects of drugs used to treat irritable bowel syndrome including lubiprostone, but not linaclotide or plecanatide). 22444104
Camilleri M. Guanylate cyclase C agonists: emerging gastrointestinal therapies and actions. Gastroenterology 2015; 148: 483-7. (Review of the role of guanylate cyclase C in intestinal physiology and the effects of agonists [bacterial enterotoxins, linaclotide and plecanatide] on intercellular signaling, enterocyte chloride secretion and intestinal peristalsis, as well as their clinical effects and role in management of chronic idiopathic constipation and constipation predominant irritable bowel syndrome). 25576859
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to metoclopramide, but none to other prokinetic agents or drugs for chronic idiopathic constipation). 25754159
DeMicco M, Barrow L, Hickey B, Shailubhai K, Griffin P. Randomized clinical trial: efficacy and safety of plecanatide in the treatment of chronic idiopathic constipation. Therap Adv Gastroenterol 2017; 10: 837-51. (Among 1337 patients with chronic idiopathic constipation treated with plecanatide [3 or 6 mg] vs placebo once daily for 12 weeks, plecanatide improved stool frequency and consistency and adverse events were uncommon, the most frequent being diarrhea which arose in 3.2% and 4.5% on plecanatide vs 1.3% on placebo and “laboratory findings…were all unremarkable, with low incidence of any clinically important change”). 29147135
Miner PB Jr, Koltun WD, Wiener GJ, De La Portilla M, Prieto B, Shailubhai K, Layton MB, et al. A randomized phase III clinical trial of plecanatide, a uroguanylin analog, in patients with chronic idiopathic constipation. Am J Gastroenterol 2017; 112: 613-21. (Among 1394 patients with chronic idiopathic constipation treated with plecanatide [3 or 6 mg] or placebo once daily for 12 weeks, spontaneous bowel movements increased by 3.1 to 3.2 per week with plecanatide vs 1.2 on placebo and adverse events were uncommon, diarrhea arose in 5.9% and 5.7% vs 1.3% of patients and “laboratory findings...were all unremarkable, with low incidence of any clinical important changes”). 28169285
Al-Salama ZT, Syed YY. Plecanatide: first global approval. Drugs 2017; 77: 593-8. (Review of mechanism of action, history of development, pharmacology, clinical efficacy and safety; adverse events more frequent with plecanatide than placebo included diarrhea [5% vs 1%], abdominal distension, abdominal tenderness and increase in serum aminotransferase levels above 5 times ULN [ALT 0.2%, AST 0.3%]). 28255961
Plecanatide (Trulance) for chronic idiopathic constipation. Med Lett Drugs Ther 2017; 59 (1519): 66-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of plecanatide shortly after its approval for use in chronic idiopathic constipation in the United States; discusses diarrhea as the most frequent adverse event, but also mentions the adverse event reaction of liver enzyme elevations). 28419073
Brenner DM, Fogel R, Dorn SD, Krause R, Eng P, Kirshoff R, Nguyen A, et al. Efficacy, safety, and tolerability of plecanatide in patients with irritable bowel syndrome with constipation: results of two phase 3 randomized clinical trials. Am J Gastroenterol 2018; 113: 735-45. (Among 2189 persons with constipation predominant irritable bowel syndrome enrolled in 2 clinical trials of plecanatide [3 or 6 mg] vs placebo once daily for 12 weeks, clinical responses were more frequent with plecanatide and the most frequent side effect was diarrhea [4.0% and 4.3% vs 1%] and discontinuations were uncommon [1.2% and 1.4% vs none]; no mention of ALT elevations or hepatotoxicity). 29545635
Black CJ, Ford AC. Chronic idiopathic constipation in adults: epidemiology, pathophysiology, diagnosis and clinical management. Med J Aust 2018; 209: 86-91. (Review of the role of guanylate cyclase C in gastrointestinal physiology and the biologic basis for the use of guanylate cyclase receptor agonists as therapy of gastrointestinal disorders). 29996755
Waldman SA, Camilleri M. Guanylate cyclase-C as a therapeutic target in gastrointestinal disorders. Gut 2018; 67: 1543-52. (Review of the definition, diagnosis, epidemiology, pathophysiology, clinical features and management and drug therapy of chronic idiopathic constipation). 29563144

## OTHER REFERENCE LINKS

1. Recent References on Plecanatide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Plecanatide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Plecanatide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Plecanatide)